# Gout Medications

## OVERVIEW

Gout is a common metabolic disorder caused by high body uric acid levels, and marked by episodic deposition of uric acid crystals in joints (acute gouty arthritis) and other tissues such as the kidney (urate nephropathy or nephrolithiasis). The underlying condition appears to be an increase in total body uric acid stores and is usually marked by hyperuricemia. Hyperuricemia is typically defined as serum uric acid levels greater than 7.0 mg/dL. Gout is more common in men than women and usually has its onset in 4th or 5th decade of life. Approximately 1% of adult Americans report having gout and 5% have some degree of hyperuricemia.

Management of gout can be directed at treatment of acute attacks of gouty arthritis or to long term maintenance therapy directed at preventing attacks or decreasing the risk of uric acid nephropathy or nephrolithiasis. Treatment of acute attacks usually rests on use of nonsteroid antiinflammatory agents such as indomethacin, naproxen, sulindac or celecoxib. Colchicine (1961: Colbenemid and others) is used both during acute episodes and in chronic maintenance therapy. However, the major approach to long term prevention of gout and the complications of uric acid nephropathy is the use of uricosuric acids such as probenecid (1951: Benuryl) and benzbromarone (not available in the United States) and/or inhibitors of xanthine oxidase, such as the xanthine derivative allopurinol (1966: Aloprim) and the newer nonnucleoside xanthine oxidase inhibitors such as febuxostat (2009: Uloric, Adenuric).

Newer approaches to gout include use of lesinurad (Zurampic: 2015), a drug that inhibits the reabsorption of uric acid in the distal tubules of the kidney, and use of recombinant enzymes that metabolize uric acid such as pegloticase (Kystexxa), which is used in combination with xanthine oxidase inhibitors ito treat severe gout, and rasburicase (Elitek: 2002) which is used to treat the hyperuricemia associated with tumor lysis syndrome induced by cancer chemotherapy.

Allopurinol is a well known cause of acute liver disease that can be severe. Benzbromarone has been linked to several cases of severe acute liver injury, for which reason it was not approved for use in the United States. The other medications for gout are exceedingly rare causes of clinically apparent, acute liver injury.

The following drugs are discussed individually:

- Allopurinol
- Benzbromarone
- Colchicine
- Febuxostat
- Lesinurad
- Pegloticase
- Probenecid
- Rasburicase

## REFERENCES

References updated: 19 July 2017

Zimmerman HJ. Drugs used to treat gout. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 542-4. (Textbook of hepatotoxicity published in 1999 and before the availability of lesinurad).
Grosser T, Smyth E, FitzGerald GA. Anti-inflammatory, antipyretic, and analgesic agents: pharmacotherapy of gout. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 959-1004. (Textbook of pharmacology and therapeutics).
Drugs for gout. Med Lett Drugs Ther 2014; 56 (1438): 22-4. (Update on medications for gout discusses the urate lowering agents allopurinol, febuxostat, probenecid and pegloticase, but not lesinurad). 24791281
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 8 cases were attributed to drugs used for gout [allopurinol in 7 and febuxostat in 1], but no cases were attributed to lesinurad). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Antigout Agents: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=gout+suppressants/AE+AND+human%5Bmh%5D+AND+(liver+diseases/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+jaundice/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222006/4/15%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Antigout Agents: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=gout+suppressants)